# Everolimus

## OVERVIEW

### Introduction

Everolimus is an inhibitor of cell proliferation and immunosuppressive agent that is used alone or in combination with calcineurin inhibitors to prevent cellular rejection after organ transplantation, and in combination with other anticancer agents as treatment of advanced renal cell and other cancers. Everolimus therapy can be associated with mild serum enzyme elevations, but has yet to be linked to instances of clinically apparent liver injury with jaundice.

### Background

Everolimus (e" ver oh' li mus) binds to the same intracellular receptor as tacrolimus and cyclosporine, but does not inhibit calcineurin; rather, it blocks the "mammalian target of rapamycin" (mTOR), which interrupts signaling pathways of several cytokines and growth factors including IL2 and causes a decrease in protein synthesis and cell cycle arrest. Everolimus therapy has been shown to improve graft survival after solid organ transplantation and to improve time to progression in several forms of cancer. Everolimus was approved for use in the United States in 2009 initially as an agent to prevent rejection after kidney and liver transplantaiton and later, in higher doses, as therapy of advanced renal cell, breast and pancreatic neuroendocrine cancers given alone or in combination with other antineoplastic agents. More recently, everolimus was approved as therapy of renal angiomyolipoma and subependymal giant cell astrocytoma associated with tuberous sclerosis complex (in which mTOR signaling is dysregulated). Everolimus like sirolimus is also used in drug eluting arterial stents, to prevent stenosis. Everolimus is available as tablets of 0.25, 0.50 and 0.75 mg under the brand name of Zortress for management of solid organ transplantation, and as tablets of 2.5, 5, 7.5 and 10 mg under the brand name of Afinitor, and tablets of 2, 3 and 5 mg for oral suspension under the brand name Afinitor-Disprez for use in cancer chemotherapy. The typical dose in organ transplantation is 1.0 to 1.5 mg in two divided doses daily but therapeutic drug level monitoring for dosing is recommended. The doses using in cancer chemotherapy are higher than those used in prevention of organ rejection, usually starting at 10 mg once daily and varying somewhat by indication. Everolimus is less nephrotoxic than the calcineurin inhibitors but does have many, largely dose dependent side effects including oral ulcers, somatitis, diarrhea, nausea, poor appetite, fatigue, peripheral edema, rash, anemia, impaired wound healing and renal dysfunction. Less common but potentially severe adverse events include interstitial pneumonitis, reanl failure, hypersensitivity reactions and embryo-fetal toxicity.

### Hepatotoxicity

Serum enzyme elevations occur in up to a quarter of patients taking everolimus, but the abnormalities are usually mild, asymptomatic and self-limiting, rarely requiring dose modification or discontinuation. Liver test elevations above 5 times ULN occur in only 1% to 2% of treated patients. In contrast, idiosyncratic, clinically apparent acute liver injury has not been linked to everolimus therapy despite its wide scale use in several malignant and non-malignant syndromes. Elevations in serum enzymes and bilirubin and hepatitis are listed as potential adverse events in the product label for everolimun. Thus, acute clinically apparent liver injury with jaundice due to everolimus is probably quite rare, if it occurs at all.

Importantly, everolimus is immunosuppressive and therapy in patients with cancer has been associated with episodes of reactivation of hepatitis B, which can be severe and even fatal. Reverse seroconversion (development of HBsAg in a person with preexisting antibody to hepatitis B, either anti-HBs or anti-HBc) has also been reported.

Likelihood score: E* (unproven and also unlikely cause of clinically apparent liver injury but capable of inducing reactivation of hepatitis B).

### Mechanism of Injury

Everolimus undergoes extensive hepatic metabolism, largely via the cytochrome P450 system (CYP 3A4) and P-glycoprotein. Liver injury might be due to a direct effect of everolimus or to a toxic intermediate of its metabolism. Everolimus is prone to drug-drug interactions if used with inhibitors or inducers of the cytochrome P450 drug metabolizing enzymes.

### Outcome and Management

Acute liver injury with jaundice associated with everolimus therapy has not been described, and the serum enzyme elevations associated with its use are usually mild and transient, resolving spontaneously or with dose modification. Because everolimus can lead to reactivation of chronic hepatitis B, routine screening of patients for HBsAg and anti-HBc before starting therapy is advisable, particularly those undergoing organ transplantation. Patients with HBsAg or anti-HBc should be offered prophylaxis or some degree of monitoring for de novo appearance or rise in levels of HBV DNA. Patients who develop reactivation should be treated with an oral nucleoside analogue with potent activity against hepatitis B (entecavir or tenofovir alafenamide). Everolimus is a macrolide similar in structure and function to sirolimus and temsirolimus, but these agents do not always exhibit cross sensitivity to adverse effects.

Agents used specifically for the prophylaxis against allograft rejection include cyclosporine, everolimus, mycophenolate mofetil, sirolimus and tacrolimus, as well as azathioprine and corticosteroids.

Drug Class: Antineoplastic Agents, Miscellaneous; Transplant Agents

Other Drugs in the Class, Transplant Drugs: Cyclosporine, Mycophenolate, Sirolimus, Tacrolimus

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Everolimus – Zortress®

DRUG CLASS

Antineoplastic Agents; Transplant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Everolimus)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Everolimus | 159351-69-6 | C53-H83-N-O14 | Everolimus Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 26 February 2018

Zimmerman HJ. Cyclosporine. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp.697-8. (Expert review of hepatotoxicity published in 1999; everolimus and temsirolimus are not discussed).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 569-91. (Review of hepatotoxicity of immunosuppressive agents; mentions that reports of hepatotoxicity of everolimus have been less frequent than those of sirolimus [rapamycin]).
Chabner BA, Barnes J, Neal J, Olson E, Mugagic H, Sequist L, Wilson W, Longo DL, Mitsiades C, Richardson P. Targeted therapies: tyrosin kinase inhibitors, monoclonal antibodies and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Levy G, Schmidli H, Punch J, Tuttle-Newhall E, Mayer D, Neuhaus P, Samuel D, et al. Safety, tolerability, and efficacy of everolimus in de novo liver transplant recipients: 12- and 36-month results. Liver Transpl 2006; 12: 1640-8. (Controlled trial of everolimus vs placebo for 12-36 months in 119 liver transplant recipients also taking cyclosporine and corticosteroids found "no clinically meaningful changes from baseline" in ALT, Alk P or bilirubin). 16598777
Tedesco-Silva H Jr, Vitko S, Pascual J, Eris J, Magee JC, Whelchel J, Civati G, et al.; 2306 and 2307 study groups. 12-month safety and efficacy of everolimus with reduced exposure cyclosporine in de novo renal transplant recipients. Transpl Int 2007; 20: 27-36. (Controlled trial of 2 doses of everolimus with cyclosporine with or without basiliximab in 237 patients undergoing renal transplantation; no mention of ALT elevations or hepatotoxicity). 17181650
Reinisch W, Pané J, Lénn M, Schreiber S, Feagan B, Schmidt S, Sturniolo GC, et al. A multicenter, randomized, double-blind trial of everolimus versus azathioprine and placebo to maintain steroid-induced remission in patients with moderate-to-severe active Crohn's disease. Am J Gastroenterol 2008; 103: 2284-92. (Controlled trial of everolimus vs azathioprine vs placebo as maintenance therapy in 144 adults with Crohn Disease, found no effect of everolimus; serum ALT levels rose slightly in everolimus vs placebo treated patients [mean 38 U/L at 3 months vs 17 U/L at baseline], but there were no hepatic serious adverse events). 18671816
Ettenger R, Hoyer PF, Grimm P, Webb N, Loirat C, Mahan JD, Mentser M, et al.; Everolimus Pediatric Study Group. Multicenter trial of everolimus in pediatric renal transplant recipients: results at three year. Pediatr Transplant 2008; 12: 456-63. (Open label study of everolimus and cyclosporine in 19 children undergoing renal transplantation; ALT elevations [above 3 times ULN] occurred in 33%, but there were no severe hepatic adverse reactions or discontinuations due to liver injury). 18466433
Chan L, Greenstein S, Hardy MA, Hartmann E, Bunnapradist S, Cibrik D, Shaw LM, et al.; CRADUS09 Study Group. Multicenter, randomized study of the use of everolimus with tacrolimus after renal transplantation demonstrates its effectiveness. Transplantation 2008; 85: 821-6. (Open label study of 92 renal transplant patients given everolimus with standard or low dose tacrolimus for at least 6 months; ALT elevations and liver toxicity were not listed among "most relevant" adverse events). 18360262
Ellard SL, Clemons M, Gelmon KA, Norris B, Kennecke H, Chia S, Pritchard K, et al. Randomized phase II study comparing two schedules of everolimus in patients with recurrent/metastatic breast cancer: NCIC Clinical Trials Group IND.163. J Clin Oncol 2009; 27: 4536-41. (Trial comparing daily vs weekly everolimus in 15 patients with advanced breast cancer; no mention of ALT elevations or liver toxicity). 19687332
Baselga J, Semiglazov V, van Dam P, Manikhas A, Bellet M, Mayordomo J, Campone M, et al. Phase II randomized study of neoadjuvant everolimus plus letrozole compared with placebo plus letrozole in patients with estrogen receptor-positive breast cancer. J Clin Oncol 2009; 27: 2630-7. (270 women with breast cancer were treated with a 4 month course of letrozole with or without everolimus; ALT elevations occurred in 12% on everolimus [above 5 times ULN in 1.5%] vs 4% on placebo [all less than 5 times ULN], but no mention of clinically apparent liver injury). 19380449
Gabardi S, Baroletti SA. Everolimus: a proliferation signal inhibitor with clinical applications in organ transplantation, oncology, and cardiology. Pharmacotherapy 2010; 30: 1044-56. (Systematic review of safety and efficacy of everolimus in organ transplantation and oncology mentioned liver test elevations as an adverse event; no mention of clinically apparent liver injury). 20874042
Motzer RJ, Escudier B, Oudard S, Hutson TE, Porta C, Bracarda S, Grünwald V, et al.; RECORD.1 Study Group. Phase 3 trial of everolimus for metastatic renal cell carcinoma: final results and analysis of prognostic factors. Cancer 2010; 116: 4256-65. (Controlled trial of everolimus [10 mg/day] vs placebo in 416 patients with metastatic renal cell carcinoma for 19 to 455 days; side effects included pneumonitis [14% vs 0%] and ALT elevations [21% vs 4%], but most were less than 5 times ULN and no mention of clinically apparent liver injury). 20549832
Zuckermann A, Wang SS, Ross H, Frigerio M, Eisen HJ, Bara C, Hoefer D, et al. Efficacy and safety of low-dose cyclosporine with everolimus and steroids in de novo heart transplant patients: a multicentre, randomized trial. J Transplant 2011; 2011: 535983. (Open label 6 month study of everolimus with standard or reduced doses of cyclosporine in 199 heart transplant recipients; no mention of ALT elevations or liver toxicity). 22295178
Grgic T, Mis L, Hammond JM. Everolimus: a new mammalian target of rapamycin inhibitor for the treatment of advanced renal cell carcinoma. Ann Pharmacother 2011; 45: 78-83. (Systematic review of everolimus [5-10 mg/day] as therapy of renal cell carcinoma; major side effects are mucositis [40%], rash [25%], fatigue [20%] and liver test abnormalities [proportion not given]). 21177421
Oberstein PE, Saif MW. Safety and efficacy of everolimus in adult patients with neuroendocrine tumors. Clin Med Insights Oncol 2012; 6: 41-51. (Review of safety and efficacy of everolimus as therapy of neuroendocrine tumors; common side effects are mucositis [64%], rash [49%], diarrhea [34%] and infections [23%], including reactivation of hepatitis B; no mention of ALT elevations or hepatotoxicity). 22253554
Holdaas H, Midtvedt K, Åsberg A. A drug safety evaluation of everolimus in kidney transplantation. Expert Opin Drug Saf 2012; 11: 1013-22. (Review and opinion of pharmacology, mechanism of action, efficacy and safety of everolimus in renal transplantation; no mention of ALT elevations or hepatotoxicity). 22954349
Thompson LA, Kim M, Wenger SD, O'Bryant CL. Everolimus: a new treatment option for advanced pancreatic neuroendocrine tumors. Ann Pharmacother 2012; 46: 1212-9. (Review of safety and efficacy of everolimus in advanced pancreatic endocrine tumors; side effects include mucositis, rash, diarrhea, fatigue, infections, nausea, edema, poor appetite and pneumonitis; no mention of ALT elevations or hepatotoxicity). 22947595
Baselga J, Campone M, Piccart M, Burris HA 3rd, Rugo HS, Sahmoud T, Noguchi S, et al. Everolimus in postmenopausal hormone-receptor-positive advanced breast cancer. N Engl J Med 2012; 366: 520-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/22149876) (Among 724 postmenopausal women with advanced, refractory breast cancer treated with exemestane with or without everolimus, progression-free survival was greater with everolimus [6.9 vs 2.8 months] as were serious adverse event rates [23% vs 12%] and total ALT elevations [11% vs 3%], but less than 1% were above 5 times ULN and there were no instances of clinically apparent liver injury).
Shiah HS, Chen CY, Dai CY, Hsiao CF, Lin YJ, Su WC, Chang JY, et al. Randomised clinical trial: comparison of two everolimus dosing schedules in patients with advanced hepatocellular carcinoma. Aliment Pharmacol Ther 2013; 37: 62-73. (Open label study of different dose regimens of everolimus in 39 patients with hepatocellular carcinoma found ALT flares after 4-16 weeks in 5 patients [one with jaundice], 4 had hepatitis B, and ALT rises were associated with reactivation and responded to stopping everolimus and starting lamivudine therapy). 23134470
Pallet N, Legendre C. Adverse events associated with mTOR inhibitors. Expert Opin Drug Saf 2013; 12: 177-86. (Review of side effects of the mTor inhibitors focusing largely on sirolimus; no discussion of hepatotoxicity). 23252795
Krueger DA, Care MM, Agricola K, Tudor C, Mays M, Franz DN. Everolimus long-term safety and efficacy in subependymal giant cell astrocytoma. Neurology 2013; 80: 574-80. (Abstract only: Long term follow up on 28 patients with tuberous sclerosis and subependymal giant cell astrocytoma treated for 5-47 months with everolimus; most side effects were mild and none led to discontinuation). 23325902
Bissler JJ, Kingswood JC, Radzikowska E, Zonnenberg BA, Frost M, Belousova E, Sauter M, et al. Everolimus for angiomyolipoma associated with tuberous sclerosis complex or sporadic lymphangioleiomyomatosis (EXIST-2): a multicentre, randomised, double-blind, placebo-controlled trial. Lancet 2013; 381 (9869): 817-24. (Among 118 adults with angiomyolipoma treated with everolimus or placebo for up to 2 years, common side effects were stomatitis, nasopharyngitis, acne, headache, cough and hypercholesterolemia; no mention of ALT changes or hepatotoxicity). 23312829
van den Eertwegh AJ, Karakiewicz P, Bavbek S, Rha SY, Bracarda S, Bahl A, Ou YC, et al. Safety of everolimus by treatment duration in patients with advanced renal cell cancer in an expanded access program. Urology 2013; 81: 143-9. (Analysis of side effects among 1367 patients with renal cell cancer treated with everolimus in an expanded access program; common side effects were dyspnea, anemia, fatigue, stomatitis, pneumonitis and hyperglycemia; no mention of ALT elevations or hepatotoxicity). 23273080
Mizuno S, Yamagishi Y, Ebinuma H, Nakamoto N, Katahira M, Sasaki A, Sakamoto M, et al. Progressive liver failure induced by everolimus for renal cell carcinoma in a 58-year-old male hepatitis B virus carrier. Clin J Gastroenterol 2013; 6: 188-92. (58 year old man with inactive HBsAg carrier state and refractory renal cell cancer developed reactivation of HBV 5 months after starting everolimus [bilirubin 11.0 mg/dL, ALT 878 U/L, HBV DNA 10 million copies/mL, INR 1.8], with progressive liver failure despite entecavir and methylprednisolone therapy, and death 6 weeks after presentation). 23606919
Sezgin Göksu S, Bilal S, Coşkun HŞ. Hepatitis B reactivation related to everolimus. World J Hepatol 2013; 5: 43-5. (49 year old man with inactive HBsAg carrier state and refractory renal cell cancer developed reactivation of HBV 3-5 months after starting everolimus [bilirubin 16.3 mg/dL, ALT 1871 U/L, HBV DNA 1.2 billion copies/mL, protime 14.8 seconds], starting to resolve 20 days after stopping everolimus and starting tenofovir). 23383366
Teplinsky E, Cheung D, Weisberg I, Jacobs RE, Wolff M, Park J, Friedman K, et al. Fatal hepatitis B reactivation due to everolimus in metastatic breast cancer: case report and review of literature. Breast Cancer Res Treat 2013; 141: 167-72. (56 year old woman with advanced metastatic breast cancer developed jaundice 4 months after starting everolimus [bilirubin 8.0 mg/dL, ALT 1758 U/L, Alk P 154 U/L, HBsAg and HBV DNA positive, IgM anti-HBc negative], with progression to hepatic failure and death despite tenofovir therapy). 24002736
Schieren G, Bölke E, Scherer A, Raffel A, Gerber PA, Kröpil P, Schott M, et al. Severe everolimus-induced steatohepatis: a case report. Eur J Med Res 2013; 18: 22. (76 year old man with metastatic neuroendocrine cancer developed ascites and liver test abnormalities 4 weeks after starting everolimus [bilirubin normal, ALT 16 U/L, GGT 1599 U/L], and CT scans of the liver suggested diffuse steatosis and expanding hepatic masses, the patient dying of multiorgan failure 2 weeks later, and there was no verification of steatosis histologically). 23822543
Sterneck M, Kaiser GM, Heyne N, Richter N, Rauchfuss F, Pascher A, Schemmer P, et al. Everolimus and early calcineurin inhibitor withdrawal: 3-year results from a randomized trial in liver transplantation. Am J Transplant 2014; 14: 701-10. (Among 203 liver transplant recipients switched to everolimus or maintained on calcineurin inhibitors 1 month after transplantation, 81 were enrolled in an extension study for up to 3 years; mean ALT, AST and GGT levels did not differ between those receiving or not receiving everolimus). 24502384
Piccart M, Hortobagyi GN, Campone M, Pritchard KI, Lebrun F, Ito Y, Noguchi S, et al. Everolimus plus exemestane for hormone-receptor-positive, human epidermal growth factor receptor-2-negative advanced breast cancer: overall survival results from BOLERO-2†. Ann Oncol 2014; 25: 2357-62. (Among 724 women with advanced breast cancer treated with exemestane with or without everolimus [Baselga 2012], further follow up demonstrated higher overall survival for the combination [31 vs 27 months] but also higher rates of serious adverse events [33% vs 16%], discontinuations for adverse events [29% vs 5%] and drug related deaths [1.7% vs 0.4%], but none were considered liver related deaths). 25231953
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2025754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to antineoplastic agents, but none were linked to use of everolimus).
Abdel-Rahman O, Fouad M. Risk of fatigue and hepatic and metabolic toxicities in patients with solid tumors treated with everolimus: a meta-analysis. Future Oncol 2015; 11: 79-90. (A review of the literature on adverse events in cancer patients treated with everolimus mentions ALT elevations above 5 times ULN in 4 publications [0% to 4%], but does not mention clinically apparent liver injury). 25572784
Goldberg HJ, Harari S, Cottin V, Rosas IO, Peters E, Biswal S, Cheng Y, et al. Everolimus for the treatment of lymphangioleiomyomatosis: a phase II study. Eur Respir J 2015; 46: 783-94. (Among 24 women with lymphangioleiomyomatosis treated with everolimus [2.5 to 10 mg daily] for 26 weeks, pulmonary function improved and common adverse events included stomatitis [92%], headache [38%], nausea [29%] and fatigue [29%], while serious adverse events occured in one-third of patients and included heart failure, edema, pneumonitis and P. jirovecii pneumonia; no mention of ALT elevations or hepatotoxicity). 26113676
Mir O, Toulmonde M, Coriat R, Ropert S, Loulergue P. Hepatitis B reactivation during everolimus treatment. Acta Oncol 2016; 55: 1505-6. (51 year old French woman with previous history of hepatitis B, but undocumented serology developed symptomatic acute hepatitis 3 months after starting everolimus and exemestane for refractory, advanced breast cancer [bilirubin 6.3 mg/dL, ALT 3.5 times ULN, HBsAg positive and HBV DNA 60 million copies/mL], improving with stopping everolimus and starting entecavir). 27771976
D'Aniello C, Maruzzo M, Basso U. Prevention of hepatitis B virus reactivation with lamivudine in a patient with advanced renal cell carcinoma treated with everolimus. Am J Ther 2016; 23: e300-3. (An HBsAg positive patient with metastatic renal cancer was treated with lamivudine prophylactically and had no evidence of hepatitis B reactivation during therapy with high doses of everolimus: Abstract only). 24368609
Moscetti L, Vici P, Gamucci T, Natoli C, Cortesi E, Marchetti P, Santini D, et al. Safety analysis, association with response and previous treatments of everolimus and exemestane in 181 metastatic breast cancer patients: A multicenter Italian experience. Breast 2016; 29: 96-101. (Among 181 women with advanced breast cancer treated with the combination of everolimus and exemestane for a median duration of 18 months, adverse events were common and included "hepatic" events in 35 patients [19%], but only 5 [2.8%] were above "grade 3" [above 5 times ULN for ALT and AST]). 27476084
Jerusalem G, Mariani G, Ciruelos EM, Martin M, Tjan-Heijnen VC, Neven P, Gavila JG, et al. Safety of everolimus plus exemestane in patients with hormone-receptor-positive, HER2-negative locally advanced or metastatic breast cancer progressing on prior non-steroidal aromatase inhibitors: primary results of a phase IIIb, open-label, single-arm, expanded-access multicenter trial (BALLET). Ann Oncol 2016; 27: 1719-25. (Among 2133 postmenopausal women with advanced breast cancer treated with exemestane with or without everolimus for a median of 5 months, everolimus related serious adverse events occurred in 8.5% of treated subjects and was the suspected cause of death in 4, but details not provided). 27358383
Armstrong AJ, Halabi S, Eisen T, Broderick S, Stadler WM, Jones RJ, Garcia JA, et al. Everolimus versus sunitinib for patients with metastatic non-clear cell renal cell carcinoma (ASPEN): a multicentre, open-label, randomised phase 2 trial. Lancet Oncol 2016; 17: 378-88. (Among 108 patients with metastatic renal cell carcinoma treated with everolimus or sunitinib, overall survival was similar and adverse events were common in both groups, but ALT elevations were infrequent and mild, arising in 0% on everolimus and 10% on sunitinib [all of which were less than 5 times ULN] and there were no instances of clinically apparent liver injury). 26794930
Takasaki S, Kikuchi M, Kawasaki Y, Ito A, Arai Y, Yamaguchi H, Mano N. [A case of renal cell carcinoma with high everolimus blood concentrations and hyperglycemia due to everolimus-induced hepatic dysfunction]. Gan To Kagaku Ryoho 2017; 44: 87-9. Japanese. (74 year old man with metastatic renal cell carcinoma developed hyperglycemia and liver enzyme elevations during everolimus therapy [peak ALT 115 U/L] which improved on stopping and recurred on restarting [ALT ~60 U/L], which resolved when he was switched to axitinib [a tyrosine kinase receptor inhibitor also used to treat renal cell carcinoma]). 28174388
Christopoulos P, Engel-Riedel W, Grohé C, Kropf-Sanchen C, von Pawel J, Gütz S, Kollmeier J, et al. Everolimus with paclitaxel and carboplatin as first-line treatment for metastatic large-cell neuroendocrine lung carcinoma: a multicenter phase II trial. Ann Oncol 2017; 28: 1898-902. (Among 49 patients with metastatic neuroendocrine lung cancer treated with everolimus, paclitaxel and carboplatin, the median overall survival was 10 months and adverse events were common [overall 89%, grade 3-4 51%], leading to dose reductions or interruptions in 30%; but ALT elevations and hepatotoxicity were not listed in Tables or mentioned). 28535181

## OTHER REFERENCE LINKS

1. Recent References on Everolimus: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Elvitegravir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Everolimus: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Elvitegravir)